# L-Glutamine

## OVERVIEW

### Introduction

L-glutamine is an essential amino acid and precursor of major intracellular antioxidant molecules that is used in high doses to prevent vaso-occlusive crises in patients with sickle cell disease. L-glutamine has not been associated with serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

L-glutamine (el gloo’ ta mene) is a conditionally essential amino acid that is approved for use in the treatment of sickle cell disease to prevent painful crises. Sickle cell disease is caused by an inherited mutation in the β globin gene that creates hemoglobin S, an abnormal form of hemoglobin which is prone to polymerization with deoxygenation resulting in sickling of red blood cells, hemolytic anemia, vascular occlusion of small vessels causing ischemic tissue and organ injury and recurrent painful crises. Sickle cell disease affects at least 100,000 Americans and is most common in persons of African descent. Long term complications include disability due to recurrent painful crises, acute chest syndrome, pulmonary hypertension, stroke and cerebral infracts, end-organ damage and early mortality. L-glutamine appears to act in decreasing painful crises in sickle cell disease by increasing levels of nicotinamide adenine dinucleotide (NAD) and glutathione, essential molecules in intracellular oxidative-reductive balance and metabolism. Sickled red cells appear to have decreased levels of reduced NAD and are susceptible to oxidative stress. Oral administration of L-glutamine can restore NAD levels towards normal. In a single, randomized controlled trial in patients with frequent sickle cell crises, high oral doses of pharmaceutic grade L-glutamine was associated with a decrease in the number of pain crises and hospitalizations, but had no effects on hemoglobin levels or reticulocyte counts. Based upon that single study, L-glutamine was approved in the United States in 2019 as therapy for sickle cell disease in adults and children 5 years or older. L-glutamine is available in powdered form in packets of 5 grams under the brand name Endari. The recommended dose, mixed with 8 oz. of beverage, varies by body weight, with twice daily doses of 5 grams if <30 kg, 10 grams if 30-65 kg, and 15 grams if >65 kg. Side effects can include fatigue, muscle and back pain, headache, abdominal pain, nausea, constipation, cough and non-cardiac chest pain.

### Hepatotoxicity

In clinical trials of L-glutamine in patients with sickle cell disease, serum aminotransferase elevations were not mentioned, and there were no reports of clinically apparent liver injury. Patients with sickle cell disease frequently have jaundice, largely due to chronic hemolysis which raises serum indirect bilirubin levels. They also can have fluctuating liver test abnormalities due to complications of sickle cell disease, such as gall stone disease (from chronic hemolysis), viral hepatitis and iron overload (from blood transfusions), congestive liver disease (due to pulmonary hypertension), and veno-occlusive crises involving the liver which can be associated with serum aminotransferase elevations and hepatic dysfunction. In preregistration trials of L-glutamine, hepatic events were not reported and serious adverse events were no more common with the active drug than with placebo. L-glutamine is a normal constituent of virtually all tissues and is unlikely to have intrinsic toxicity, even in high doses.

Glutamine supplementation has a potential of worsening hepatic encephalopathy in patients with advanced cirrhosis. Glutamine is metabolized to glutamate and ammonia which can overwhelm the hepatic elimination of ammonia in patients with severe liver dysfunction. Ingestion of 10 to 20 grams of glutamine has been shown to cause elevations of serum ammonia levels and to worsen psychometric measures of hepatic encephalopathy in patients with decompensated cirrhosis. Plasma ammonia levels do not increase with glutamine supplementation in patients with normal hepatic function, and its effects in patients with cirrhosis is not due to hepatic injury. Nevertheless, use of L-glutamine should be avoided in patients with sickle cell disease and advanced cirrhosis.

Likelihood score: E (unlikely cause of acute liver injury with jaundice).

### Mechanism of Injury

The mechanism by which L-glutamine might cause liver injury is unknown. L-glutamine is an amino acid that is used in protein synthesis in virtually all tissues and organs.

### Outcome and Management

Elucidating the cause of liver test abnormalities in patients with sickle cell disease on therapies to prevent vaso-occlusive crises is difficult, as they are susceptible to several forms of liver injury including acute viral hepatitis, hemosiderosis, gallstone disease, congestive hepatopathy and ischemic liver injury from hepatic sickling crises.

Drug Class: Genetic Disorder Agents, Hematologic Agents, Sickle Cell Disease Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

L-Glutamine – Endari®

DRUG CLASS

Sickle Cell Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=L-Glutamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
L-glutamine | 56-85-9 | C5-H10-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the reported use of L-glutamine in sickle cell disease).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/208587Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the L-glutamine application for safety and efficacy which mentions that there were “no notable differences in clinical chemistry” parameters between treatment and placebo groups).
Oppong KN, Al-Mardini H, Thick M, Record CO. (1997). Oral glutamine challenge in cirrhotics pre- and post-liver transplantation: a psychometric and analyzed EEG study. Hepatology.
(Among 17 patients with cirrhosis and 4 normal controls given oral challenges with 10 or 20 gm of glutamine, venous ammonia levels increased in those with cirrhosis [mean 58 to 120 µmol/L] but not in controls [mean 32 to 39 µmol/L], and several patients with cirrhosis had worsening of psychometric and EEG measures of subclinical hepatic encephalopathy) .
Holecek M. (2013). Side effects of long-term glutamine supplementation. JPEN J Parenter Enteral Nutr.
(Review of the potential adverse events of long term administration of glutamine supplementation in parenteral nutrition mentions that the metabolism of glutamine to glutamate generates ammonia which may overwhelm or circumvent hepatic metabolism) .
Koh C, Turner T, Zhao X, Minniti CP, Feld JJ, Simpson J, Demino M, et al. (2013). Liver stiffness increases acutely during sickle cell vaso-occlusive crisis. Am J Hematol. (Among 23 patients with sickle cell disease evaluated before and during an acute vaso-occlusive crisis, serum liver enzyme elevations did not change appreciably but hepatic stiffness increased [measured by ultrasound transient elastography] as did serum total and indirect bilirubin and reticulocyte counts, while serum albumin and hemoglobin decreased).
Feld JJ, Kato GJ, Koh C, Shields T, Hildesheim M, Kleiner DE, Taylor JG, et al. (2015). Liver injury is associated with mortality in sickle cell disease. Aliment Pharmacol Ther. (Among 247 patients with sickle cell disease, liver disease was common, elevations in ALT were present in 16% and alkaline phosphatase in 33%; factors associated with mortality during follow up were iron indices [serum ferritin, transferrin, and iron] and liver abnormalities [direct bilirubin, albumin and alkaline phosphatase levels]; liver biopsy done in 40 patients revealed nodular regenerative hyperplasia in 36% and portal venopathy in 23%).
(2018). L-glutamine (Endari) for sickle cell disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of L-glutamine for sickle cell disease describes its adverse effects to include constipation, nausea, headache, abdominal pain, pain in back and extremities, cough and chest pain but does not mention ALT elevations or hepatotoxicity).
Quinn CT. (2018). L-glutamine for sickle cell anemia: more questions than answers. Blood. (Review of the evolving understanding of sickle cell disease and the pathogenesis of the painful crises focusing upon studies of oxidative stress and the possible role of L-glutamine in protecting red cells from oxidative damage; mentions the modest clinical effects of L-glutamine therapy on sickle cell crises, the lack of understanding of mechanism of action, its high cost, and possibly poor tolerance).
Niihara Y, Miller ST, Kanter J, Lanzkron S, Smith WR, Hsu LL, Gordeuk VR, et al. (2018). Investigators of the Phase 3 Trial of l-Glutamine in Sickle Cell Disease. A phase 3 trial of L-glutamine in sickle cell disease. N Engl J Med. (Among 230 patients with sickle cell disease, ages 5 to 58 years, treated with L-glutamine [0.3 gm/kg] or placebo twice daily for 48 weeks, painful crises were less frequent with L-glutamine that placebo [mean 3.2 vs 3.9 crises per year], while both total and severe adverse event rates were similar in the two groups; no mention of ALT elevations or hepatotoxicity).
Osunkwo I, Manwani D, Kanter J. (2020). Current and novel therapies for the prevention of vaso-occlusive crisis in sickle cell disease. Ther Adv Hematol. (Extensive review of the pathogenesis of sickle cell vaso-occlusive crises and potential therapeutic avenues for their prevention and treatment including induction of hemoglobin F [hydroxyurea], decreasing oxidative stress [L-glutamine], decreasing red cell adhesion [crizanlizumab], and inhibition of hemoglobin S polymerization).
Darbari DS, Sheehan VA, Ballas SK. (2020). The vaso-occlusive pain crisis in sickle cell disease: definition, pathophysiology, and management. Eur J Haematol. (Extensive review of the pathogenesis of vaso-occlusive crisis in patients with sickle cell disease and therapies that target different steps in the process including inflammation, adhesion, oxidative stress, and oxygen affinity and stability of hemoglobin; discusses efficacy of L-glutamine, voxelotor and crizanlizumab, mentioning that all three are well tolerated; no mention or discussion of hepatotoxicity).
Ali MA, Ahmad A, Chaudry H, Aiman W, Aamir S, Anwar MY, Khan A. (2020). Efficacy and safety of recently approved drugs for sickle cell disease: a review of clinical trials. Exp Hematol. (Review of randomized controlled trials of 3 recently approved drugs for sickle cell disease focusing upon L-glutamine, voxelotor, and crizanlizumab states that all three are “well tolerated without any alarming adverse effects”; no mention of ALT elevations or hepatotoxicity).
Pace BS, Starlard-Davenport A, Kutlar A. (2021). Sickle cell disease: progress towards combination drug therapy. Br J Haematol. (Review of the pathophysiology of sickle cell disease and vaso-occlusive crises and mechanism of action of drugs used to treat sickle cell disease and drugs currently under investigation for efficacy in decreasing the microvascular occlusive crises that mediate much of the morbidity and mortality of this disease).

## OTHER REFERENCE LINKS

1 Recent References on L-glutamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=L-glutamine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on L-glutamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=L-glutamine)